# Tirzepatide

## OVERVIEW

### Introduction

Tirzepatide is an agonist of the receptors of two insulin sensitizing polypeptides, GIP (glucose-dependent insulinotropic polypeptide) and GLP-1 (glucagon-like peptide 1), that is used as therapy of type 2 diabetes, obstructive sleep apnea, and obesity. Tirzepatide has been linked to minimal instances of elevations in serum aminotransferase levels during therapy and rare episodes of clinically apparent liver injury.

### Background

Tirzepatide (tir zep’ a tide) is a 39 amino acid modified peptide similar in structure to the glucose-dependent insulinotropic polypeptide (GIP) that acts as an agonist to both the GIP receptor and the glucagon-like peptide 1 (GLP-1) receptor. Tirzepatide therapy increases insulin secretion, decreases glucagon secretion and delays gastric emptying. The result is a decrease in both fasting and postprandial glucose concentrations and an increase in insulin sensitivity. Tirzepatide also results in a decrease in food intake and reduced body weight. In multiple, preregistration clinical trials, tirzepatide therapy improved glycemic control and lowered HgA1c levels in patients with type 2 diabetes. It also resulted in weight loss of 7 to 11 kilograms after 40 to 52 weeks of treatment and to 16 to 24 kilograms after 72 weeks. Tirzepatide was approved for use as an adjunct to diet and exercise in type 2 diabetes in 2022 and for obesity in 2024. It is under active evaluation as therapy for nonalcoholic steatohepatitis. Tirzepatide is available as a solution in single use vials or autoinjectors as 2.5, 5, 7.5, 10, 12.5 and 15 mg (in 0.5 mL) under the brand name Mounjaro for therapy of diabetes and Zepbound for obesity. The recommended starting dosage is 2.5 mg subcutaneously once weekly, with gradual dose escalation in increments of 2.5 mg every 4 weeks to a maintenance dose of 5, 10 or 15 mg weekly. Common adverse events include injection site reactions and nonspecific gastrointestinal complaints of nausea, vomiting, diarrhea, constipation, decreased appetite, dyspepsia, and abdominal discomfort. Less common but potentially severe adverse events include hypersensitivity reactions, pancreatitis, gallstones and cholecystitis, hypoglycemia (when used with insulin or insulin secretagogues), suicidal ideation and behavior, aspiration during general anesthesia, and worsening of preexisting severe renal and gastrointestinal diseases. Tirzepatide has a boxed warning for risk of thyroid C-cell tumors and is contraindicated in patients with multiple endocrine neoplasia syndrome type 2 (MEN 2).

### Hepatotoxicity

In preregistration clinical trials, serum aminotransferase elevations of greater than 3 times the upper limit of normal (ULN) arose in less than 1% of patients during therapy with tirzepatide and similar rates occurred in placebo recipients and in comparator arm groups. In studies of more than 5,000 patients, there were no reports of severe liver test abnormalities or clinically apparent liver injury attributable to tirzepatide. Indeed, tirzepatide therapy is often associated with improvements in serum aminotransferase levels probably as a result of weight loss. On the other hand, tirzepatide has been associated with a slightly higher rate of acute gallbladder disease (cholelithiasis, biliary cholic and cholecystectomy) reported in 0.6% of treated patients vs none of placebo-treated patients. Gallbladder conditions are mentioned in the warning section of the product label for tirzepatide. Subsequent to its approval and more widespread use, there have been isolated case reports of acute liver injury in patients taking tirzepatide. Reported cases have been marked by a latency of 1 to 4 months, hepatocellular pattern of liver enzyme elevations, mild jaundice, and a benign, self-limited course. One patient had worsening of liver enzyme elevations on restarting, and others have later tolerated switching to a GLP-1 agonist without recurrence of liver injury. The risk for clinically apparent liver injury with long-term tirzepatide use is unknown but is likely to be very rare.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which tirzepatide might cause liver injury is unknown. It is a modified polypeptide and is metabolized to individual amino acids in multiple tissues and cell types including the liver. Because it causes weight loss, it can be accompanied by improvements in serum aminotransferase levels in patients with preexisting nonalcoholic fatty liver. The increased risk of acute gallbladder disease such as cholecystitis is probably related to the rapid weight loss that occurs with treatment.

### Outcome and Management

The product label for tirzepatide does not recommend routine monitoring of liver tests during therapy. Because of the reports of acute liver injury with its use, however, tirzepatide should be at least temporarily discontinued if serum aminotransferase levels are found to rise above 5 times the ULN or for any ALT elevations accompanied by symptoms of liver disease or jaundice. Patients with intolerance to tirzepatide may be able to tolerate GLP-1 agonists such as semaglutide or liraglutide.

Drug Class: Antidiabetic Agents, Weight Loss Agents

Other Related Drugs: Incretin-Based Drugs, Glucagon-Like Peptide-1 (GLP-1) Analogues, Liraglutide, Semaglutide

## CASE REPORT

### Case 1. Acute liver injury attributed to tirzepatide.(1)

A 65 year old white male with type 2 diabetes, on metformin for 4 years and empagliflozin for 2 years, was started on weekly subcutaneous (sc) injections of tirzepatide to improve his glycemic control. Six weeks later he developed fever, abdominal pain, and nausea followed by jaundice. On presentation, he had abdominal tenderness over the liver and had scleral icterus. He had no history of hepatitis or jaundice, did not drink alcohol, and had no risk factors for viral hepatitis. His other medications included rosuvastatin for hypercholesterolemia and ramipril and hydrochlorothiazide for hypertension (all of which he had taken for at least 10 years). Blood tests showed a total bilirubin of 5.8 mg/dL, ALT 1093 U/L, AST 629 U/L, and alkaline phosphatase 176 U/L (R = 17.9). The INR was 1.2 and albumin 4.4 g/dL. Tirzepatide, metformin, empagliflozin, and rosuvastatin were discontinued, and he was admitted for monitoring and management. Tests for hepatitis A, B, and C (including HCV RNA) were negative as were routine autoantibodies (ANA, SMA, AMA). Liver ultrasound and computerized tomography (CT) were normal. Abdominal MRI showed abnormal inflammatory enhancement in the liver parenchyma and sludge within the gallbladder without biliary dilatation. Serial liver tests demonstrated a rise in bilirubin to 7.5 mg/dL accompanied by rapid decreases in serum aminotransferase levels and increases in alkaline phosphatase levels (Table). The changes in serum enzymes resulted in cholestatic R values within 4 days of onset. A liver biopsy showed swollen injured hepatocytes around the central vein without steatosis or lobular inflammation, mild canaclicular cholestasis, and periportal bile ductural reaction. He was discharged on ramipril, hydrochlorothiazide, insulin and fish oil. He did well and was asymptomatic and had normal liver tests in follow up at 4 and 7 months after onset, but had gained 20 pounds after stopping tirzepatide and starting insulin.

#### Key Points

Medication: | Tirzepatide (2 mg sc weekly)
Pattern: | Initially hepatocellular (R=17.9), then cholestatic (R< 2.0)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 weeks
Recovery: | Complete within 1-2 months
Other medications: | Rosuvastatin, ramipril, hydrochlorothiazide, metformin, empagliflozin, multivitamins with calcium and iron, aspirin.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
6 weeks | 0 | 1093 | 176 | 5.8 | R = 17.9, Admission
| 1 | 744 | 165 | 5.8 | US & CT Scan normal
| 2 | 427 | 210 | 5.5 | R = 5.8, INR 1.0
| 3 | 298 | 300 | 6.4 | R = 2.8
| 4 | 227 | 369 | 7.5 | R = 1.8, MRI
| 6 | 298 | 466 | 4.3 | R = 1.5, INR 1.0
| 8 | 239 | 360 | 2.1
| 9 | 246 | 389 | 2.3 | Liver biopsy
| 10 | 210 | 365 | 1.9 | R = 1.4, Discharged
2 months | 13 | 122 | 299 | 1.5
| 23 | 48 | 166 | 1.0
3 months | 5 weeks | 39 | 117 | 0.7
5 months | 4 months | 23 | 80 | 0.1 | Normal values
8 months | 7 months | 23 | 93 | 0.6 | Normal, INR 1.0
Upper Limits of Normal | | 45 | 125 | 1.2

#### Comment

A middle aged man with diabetes, hypertension, and hypercholesterolemia, developed jaundice 6 weeks after starting weekly subcutaneous injections of tirzepatide to improve glycemic control. Tirzepatide was promptly discontinued but so were rosuvastatin and empagliflozin, important agents that he had been receiving for years without problems. The initial presentation was with acute hepatocellular injury. The liver injury improved with only mild increases in serum bilirubin for 4 days accompanied by a rapid drop in aminotransferase but concomitant rise in alkaline phosphatase levels. Other causes of liver disease were excluded, but imaging demonstrated the presence of biliary sludge. Actually, the clinical features were compatible with acute biliary obstruction from a common bile duct gallstone that was then rapidly passed. On expert review, this case was adjudicated as probable drug-induced liver injury from tirzepatide. Acute and transient biliary obstruction from gallstones was judged to be only possibly the cause of the liver injury. Rechallenge with tirzepatide might have been tried if it had been considered necessary. Certainly, rechallenge with rosuvastatin or empagliflozin would have been warranted if needed and a different GLP-1 tried with careful monitoring.

#### PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tirzepatide – Mounjaro®, Zepbound®

DRUG CLASS

Antidiabetic Agents, Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tirzepatide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tirzepatide | 2023788-19-2 | Protein | Polypeptide

## ANNOTATED BIBLIOGRAPHY

References updated: 27 June 2025

Abbreviations used: GIP, glucose-dependent insulinotropic polypeptide; GLP-1, glucagon-like peptide-1; HbA1c, hemoglobin A1c.
Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999; before the availability of tirzepatide).
De Marzio DH, Navarro VJ. Antidiabetic drugs. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 528-30. (Review of hepatotoxicity of antidiabetic drugs; mentions that there have been no published reports of hepatotoxicity of the GLP-1 analogues, tirzepatide is not discussed).
Powers AC, D'Alessio D. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 863-86. (Textbook of pharmacology and therapeutics; discusses glucagon-like peptide-1 and the incretin pathway and agents that act on this pathway, but does not discuss tirzepatide).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/215866Orig1s000MedR.pdf (FDA website with multidisciplinary review of safety and efficacy of tirzepatide [Mounjaro, for type 2 diabetes] mentions that marked aminotransferase elevations were uncommon and there were no severe hepatic adverse events in preregistration controlled trials, but that gallbladder disease arose in some treated patients [0.6%] but not in controls [none]).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/217806Orig1s000MedR.pdf (FDA website with multidisciplinary review of safety and efficacy of tirzepatide [Zepbound, for weight loss] mentions that serum aminotransferase levels typically decrease more with tirzepatide than placebo [-22% vs -3%] and that de novo elevations of ALT are uncommon therapy severe acute gallbladder disease was more common with tirzepatide than placebo treatment [0.4% vs none] but that it was probably due to weight loss rather than intrinsic toxicity. elevations were uncommon and there were no severe hepatic adverse events in preregistration controlled trials, but that gallbladder disease arose in some treated patients [0.6%] but not in controls [none]).
Kern E, VanWagner LB, Yang GY, Rinella ME. Liraglutide-induced autoimmune hepatitis. JAMA Intern Med. 2014;174:984-7.. (Young woman with diabetes and vitiligo developed an acute hepatitis 4 months after starting liraglutide [bilirubin 9.1 mg/dL, ALT 1123 U/L, AST 991 U/L, Alk P 90 U/L, ANA “not significantly elevated] which worsened despite stopping liraglutide but responded to corticosteroid therapy that was continued long-term). 24733687
Frias JP, Nauck MA, Van J, Kutner ME, Cui X, Benson C, Urva S, et al. Efficacy and safety of LY3298176, a novel dual GIP and GLP-1 receptor agonist, in patients with type 2 diabetes: a randomised, placebo-controlled and active comparator-controlled phase 2 trial. Lancet. 2018;392(10160):2180-2193. (Among 316 patients with type 2 diabetes treated with once weekly tirzepatide [1,5,10 and 1 5 mg], dulaglutide [1.5 mg] or placebo for 26 weeks, decreases in HbA1c levels and body weight occurred in a dose-dependent pattern with tirzepatide, and adverse events included gastrointestinal complaints and injection site reactions while cholecystitis occurred in 1 and pancreatitis in 2 of the 211 tirzepatide treated patients). 30293770
Patel AV, Jotwani PM, Lee TP. Drug-induced liver injury due to dulaglutide use. Am J Ther. 2019;26:e620-e622.. (64 year old African American man developed jaundice 2 months after starting dulaglutide for diabetes [bilirubin 3.6 mg/dL, ALT 191 U/L, AST 141 U/L, Alk P 301 U/L, INR 1.0] with HCV RNA in serum [1.4 million IU/mL] resolving over the next 4 to 5 months and no follow up of HCV status). 30870146
Hartman ML, Sanyal AJ, Loomba R, Wilson JM, Nikooienejad A, Bray R, Karanikas CA, et al. Effects of novel dual GIP and GLP-1 receptor agonist tirzepatide on biomarkers of nonalcoholic steatohepatitis in patients with type 2 diabetes. Diabetes Care. 2020; 43:1352-1355. (Reanalysis of a controlled trial in 316 patients with type 2 diabetes [Frias 2018], found a decrease in mean ALT levels and increase in adiponectin levels in patients treated with higher doses of tirzepatide [5, 10 and 15 mg], but not with the lowest dose [1 mg] or with dulaglutide or placebo for 26 weeks). 32291277
Yanovski SZ, Yanovski JA. Progress in pharmacotherapy for obesity. JAMA. 2021;326:129-130. (Brief review of the currently approved drugs for weight loss including the promising two new GLP-1 agonists, liraglutide and semaglutide, and tirzepatide which is in phase III trials in patients with obesity without diabetes). 34160571
Frías JP, Davies MJ, Rosenstock J, Pérez Manghi FC, Fernández Landó L, Bergman BK, Liu B, et al.; SURPASS-2 Investigators. Tirzepatide versus semaglutide once weekly in patients with type 2 diabetes. N Engl J Med. 2021;385:503-515. (Among 1879 patients with diabetes treated with tirzepatide [5, 10 or 15 mg] or semaglutide [1 mg] once weekly for 40 weeks, tirzepatide resulted in greater improvement in HbA1c levels and greater decrease in body weight [-7.6 to -11.2 kg vs -5.7 kg], while adverse event rates were similar, except for cholecystitis which arose in 12 of 1409 patients on tirzepatide vs no patients on semaglutide [0.9% vs 0%]; no mention of ALT elevations, mean levels decreased by 22% to 30%). 34170647
Rosenstock J, Wysham C, Frías JP, Kaneko S, Lee CJ, Fernández Landó L, Mao H, et al. Efficacy and safety of a novel dual GIP and GLP-1 receptor agonist tirzepatide in patients with type 2 diabetes (SURPASS-1): a double-blind, randomised, phase 3 trial. Lancet. 2021; 398(10295):143-155. (Among 478 diabetic patients with in adequate control treated with tirzepatide [5, 10, or 15 mg] or placebo once weekly for 40 weeks, HbA1c and fasting serum glucose levels improved and weight decreased by 7 to 9.5 kg while adverse events include nausea, diarrhea, constipation, dyspepsia, decreased appetite, and injection site reactions [2%-3%], while no patient developed pancreatitis and only 1 cholecystitis; no mention of ALT elevation or hepatoxicity). 34186022
Ludvik B, Giorgino F, Jódar E, Frias JP, Fernández Landó L, Brown K, et al. Once-weekly tirzepatide versus once-daily insulin degludec as add-on to metformin with or without SGLT2 inhibitors in patients with type 2 diabetes (SURPASS-3): a randomised, open-label, parallel-group, phase 3 trial. Lancet. 2021; 398(10300):583-598. (Among 1444 patients with type 2 diabetes on metformin treated with once weekly tirzepatide [5, 10 or 15 mg] or daily insulin, tirzepatide was associated with greater decreases in HbA1c levels and body weight [-7.5 to -12.9 kg vs +2.3 kg] while gallbladder events were recorded in 4 [0.4%] on tirzepatide, but none on insulin; no mention of ALT elevations or hepatotoxicity). 34370970
Del Prato S, Kahn SE, Pavo I, Weerakkody GJ, Yang Z, Doupis J, Aizenberg D, et al.; SURPASS-4 Investigators. Tirzepatide versus insulin glargine in type 2 diabetes and increased cardiovascular risk (SURPASS-4): a randomised, open-label, parallel-group, multicentre, phase 3 trial. Lancet. 2021; 398(10313): 1811-1824. (Among 2002 patients with poorly controlled type 2 diabetes treated with weekly injections of tirzepatide [5, 10 or 15 mg] or daily insulin glargine [titrated doses], HbA1c and fasting glucose levels improved more with tirzepatide as did weight loss [-7.1 to -13.5 kg vs +2 kg] while adverse event rates were similar except for diarrhea, nausea, vomiting, dyspepsia, constipation and decreased appetite, which were more common with tirzepatide but decreased over time; pancreatitis and cholecystitis occurred in less than 1% in all groups; no mention of ALT levels or hepatotoxicity). 34672967
Dahl D, Onishi Y, Norwood P, Huh R, Bray R, Patel H, Rodríguez Á. Effect of subcutaneous tirzepatide vs placebo added to titrated insulin glargine on glycemic control in patients with type 2 diabetes: The SURPASS-5 Randomized Clinical Trial. JAMA. 2022; 327(6):534-545. (Among 475 patients with type 2 diabetes and inadequate glycemic control despite insulin therapy treated with tirzepatide [5, 10 or 15 mg] or placebo weekly for 40 weeks, HbA1c and fasting glucose levels decreased more with tirzepatide as did body weight while adverse events more frequent with tirzepatide included nausea, vomiting, diarrhea, constipation, dyspepsia, decreased appetite; no patient developed pancreatitis and only one cholelithiasis; no mention of ALT elevations or hepatotoxicity). 35133415
Sun B, Willard FS, Feng D, Alsina-Fernandez J, Chen Q, Vieth M, Ho JD, et al. Structural determinants of dual incretin receptor agonism by tirzepatide. Proc Natl Acad Sci U S A. 2022;119: e2116506119. (Cryogenic electron microscopy determination of structure and binding of tirzepatide to the GIP- and GLP-1 receptors). 35333651
Drugs and devices for weight management. Med Lett Drugs Ther 2022;64:81-88. (Concise review of weight loss agents in current use in the US mentions that tirzepatide [an investigational agent] in doses of 5, 10 and 15 mg once weekly for 72 weeks resulted in weight loss of -16 to -24 kg [compared to +2 kg in placebo controls] in overweight and obese adults without diabetes). 35650672
Jastreboff AM, Aronne LJ, Ahmad NN, Wharton S, Connery L, Alves B, Kiyosue A, et al. Tirzepatide once weekly for the treatment of obesity. N Engl J Med. 2022;387;1434-1435. (Among 2539 obese or overweight non-diabetic adults treated with tirzepatide [5, 10 or 15 mg] or placebo once weekly for 72 weeks, weight loss was greater with tirzepatide [-16 to -24 kg] than placebo [-3 kg] and adverse events attributed to tirzepatide included nausea, vomiting, diarrhea, constipation and injection site reactions; pancreatitis occurred in 0.2% vs 0.2%, gallbladder disease in 1.2% vs 0.8%, and mean ALT levels decreased by 26% to 30% vs 13%; no mention of ALT elevations). 36239655
Frías JP, Davies MJ, Rosenstock J, Pérez Manghi FC, Fernández Landó L, Bergman BK, Liu B, et al.; SURPASS-2 Investigators. Tirzepatide versus semaglutide once weekly in patients with type 2 diabetes. N Engl J Med. 2021;385:503-515.. (Among 1879 patients with diabetes treated with tirzepatide [3 doses] or semaglutide for 40 weeks, mean HbA1c levels improved more with tirzepatide [-2.0% to -2.3%) than semaglutide [-1.9%] while adverse event rates were similar and serum ALT levels improved in both groups [-22% to -30% vs -22%]; no mention of hepatic adverse events. 34170647
Loomba R, Hartman ML, Lawitz EJ, Vuppalanchi R, Boursier J, Bugianesi E, Yoneda M, et al; SYNERGY-NASH Investigators. Tirzepatide for metabolic dysfunction-associated steatohepatitis with liver fibrosis. N Engl J Med. 2024;391:299-310.. (Among 190 adults with NASH treated with subcutaneous tirzepatide (3 doses) or placebo weekly for 52 weeks, resolution of NASH histologically was more frequent with tirzepatide [44% to 62% vs 10%], and adverse event rates were similar including severe events [6% in both] and “there was no evidence of drug-induced liver injury”). 38856224
Fontana RJ, Choi EK, Kaganove J, Dodson A. First report of tirzepatide hepatotoxicity with jaundice. Clin Gastroenterol Hepatol. 2024;22:2538-2539.. (64 year old man with 4-year history of diabetes developed nausea, abdominal pain, and jaundice 6 weeks after starting tirzepatide [2.5 mg weekly] for glucose control [bilirubin 5.8 mg/dL, ALT 1093 U/L, AST 629 U/L, Alk P 176 U/L, bilirubin 7.3 mg/dL, INR 1.3] with resolution within 6 weeks of stopping). 38964597
Abdullah I, El-Ghousain H, Alenezi M. Tirzepatide-related acute liver injury. Eur J Case Rep Intern Med. 2024;11:004813.. (24 year old obese woman developed abdominal pain 4.5 months after starting tirzepatide for weight loss and, while liver tests were initially normal, within days they rose precipitously [ALT 6212 U/L, AST 6712 U/L, Alk P 132 U/L, bilirubin 7.3 mg/dL, INR 9] and rapidly resolved after tirzepatide was stopped). 39247248
Malhotra A, Grunstein RR, Fietze I, Weaver TE, Redline S, Azarbarzin A, Sands SA, et al; SURMOUNT-OSA Investigators. Tirzepatide for the treatment of obstructive sleep apnea and obesity. N Engl J Med. 2024;391:1193-1205.. (Among 467 obese adults with obstructive sleep apnea treated for 52 weeks in 2 controlled trials, there was greater weight loss and decrease in apneic events with tirzepatide than placebo, and there were no hepatic adverse events). 38912654
Sohal A, Casanova L, Kowdley KV. A rare case of tirzepatide-induced hepatotoxicity. ACG Case Rep J. 2024;11:e01484.. (37 year old woman developed elevated serum aminotransferase levels 12 weeks after starting tirzepatide for weight loss [ALT 500 U/L, bilirubin and Alk P not provided] with improvement on stopping [ALT 110 U/L], worsening again on restarting [ALT 184 U/L], and ultimately resolving 2 months with stopping again [ALT 24 U/L). 39372916
Packer M, Zile MR, Kramer CM, Baum SJ, Litwin SE, Menon V, Ge J, et al; SUMMIT Trial Study Group. Tirzepatide for heart failure with preserved ejection fraction and obesity. N Engl J Med. 2025;392:427-437.. (Among 731 obese adults with heart failure with preserved ejection fraction who were treated for 52 weeks, death from cardiovascular disease or worsening heart failure was less with tirzepatide [10%] than placebo [15%] while adverse event rates were similar, serious adverse events occurring in 26.4% vs 25.6% of patients; no mention of ALT elevations or hepatotoxicity). 39555826
Jastreboff AM, le Roux CW, Stefanski A, Aronne LJ, Halpern B, Wharton S, Wilding JPH, et al; SURMOUNT-1 Investigators. Tirzepatide for obesity treatment and diabetes prevention. N Engl J Med. 2025;392:958-971.. (Among 2539 obese adults treated with 5, 10, or 15 mg of tirzepatide or placebo subcutaneously once weekly for 3 years, tirzepatide treated resulted in greater weight loss [-12% to -20% vs -1.3%] and a lower rate of new onset of diabetes [1.3% vs 13.3%], while both overall [85% to 88% vs 83%] and serious adverse event rates [13% to 15% vs 12%] were similar, and serum ALT and AST levels decreased with tirzepatide but remained unchanged with placebo treatment). 39536238
Phox M, Thesing J, Kilgore WR 3rd, Alderson J. Tirzepatide-induced liver injury: a rare medication side effect. ACG Case Rep J. 2025;12:e01661.. (76 year old obese woman developed fatigue and dark urine 7 weeks after starting tirzepatide for weight loss [bilirubin 3.0 mg/dL, ALT 486 U/L, Alk P 73 U/L], biopsy showing lobular inflammation and injury, and abnormalities resolving within 2 months of stopping tirzepatide). 40212859
Look M, Dunn JP, Kushner RF, Cao D, Harris C, Gibble TH, Stefanski A, et al. Body composition changes during weight reduction with tirzepatide in the SURMOUNT-1 study of adults with obesity or overweight. Diabetes Obes Metab. 2025;27:2720-2729.. (Among 160 obese adults treated with tirzepatide or placebo who underwent DXA scans before and after 72 weeks of treatment, weight loss was greater with tirzepatide but the proportion of lean vs fat mass loss [approximately 25% vs 75%] was the same in the two groups). 39996356
Aronne LJ, Horn DB, le Roux CW, Ho W, Falcon BL, Gomez Valderas E, Das S, et al; SURMOUNT-5 Trial Investigators. Tirzepatide as compared with semaglutide for the treatment of obesity. N Engl J Med. 2025 May 11. Epub ahead of print.. (Among 781 obese adults without diabetes treated with tirzepatide vs semaglutide for 72 weeks, weight loss was greater with tirzepatide [-20% vs -14%] while both overall [77% vs 79%] and serious events [4.8% vs 3.5%] were similar; no mention of ALT elevations or hepatic adverse events). 40353578

## OTHER REFERENCE LINKS

1. Recent References on Tirzepatide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tirzepatide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Tirzepatide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tirzepatide)